# Carfilzomib

## OVERVIEW

### Introduction

Carfilzomib is an irreversible proteasome inhibitor and antineoplastic agent that is used in treatment of refractory multiple myeloma. Carfilzomib is associated with a low rate of serum enzyme elevations during treatment and has been implicated to rare instances of clinically apparent, acute liver injury some of which have been fatal.

### Background

Carfilzomib (kar filz’ oh mib) is an orally available, small molecule inhibitor of the 26S proteasome, the intracellular complex that degrades proteins involved in cell signaling and cell cycle regulation. Blocking proteasome activity prevents activation of factors involved in cell growth and resistance to chemotherapy induced apoptosis, leading to cancer cell death. Carfilzomib was the second proteasome inhibitor developed as an antineoplastic agent, differing from the initial (bortezomib) in being an irreversible inhibitor and not being metabolized by the CYP 3A4 system. Clinical trials of carfilzomib in patients with multiple myeloma showed at least partial responses in patients who were resistant to other antineoplastic agents including bortezomib. Carfilzomib received accelerated approval for use in the United States in 2012 for therapy of previously treated, refractory or relapsing multiple myeloma. Carfilzomib is available in powdered form in single use vials of 60 mg under the brand name Kyprolis. The typical starting dose is 20 mg per meter-squared per day intravenously for two days each week for 3 weeks, and then in cycles after a rest period. It is typically administered with dexamethasone with or without lenalidomide. Common side effects include fatigue, nausea, diarrhea, constipation, anorexia, fatigue, dyspnea, thrombocytopenia, neutropenia, anemia peripheral neuropathy, rash and fever. Infusion reactions are not uncommon with the first cycle of carfilzomib and dexamethasone pretreatment is recommended. Other uncommon, but potentially severe side effects include peripheral neuropathy, cardiac and pulmonary toxicity, bone marrow suppression and tumor lysis syndrome.

### Hepatotoxicity

In large clinical trials of carfilzomib, elevations in serum aminotransferase levels were common, occurring in 8% to 13% of patients. However, values greater than 5 times the upper limit of normal (ULN) were uncommon, occurring in 1% to 2% of recipients. In several studies there were reports of clinically apparent liver injury including acute liver failure in patients receiving carfilzomib; however, in most instances multiple concomitant medications were being taken (such as lenalidomide) and the specific role of carfilzomib in causing the liver injury was not always clear. The onset of injury was typically during the first cycle of therapy. The clinical features and pattern of injury in clinically apparent cases of liver injury due to carfilzomib have not been described in the published literature. Hepatotoxicity is listed as a warning in the product label for carfilzomib and monitoring of serum enzymes during treatment is recommended.

Likelihood score: D (Possible cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanisms of liver injury accounting for serum enzyme elevations and hepatic toxicity during carfilzomib therapy are not known. Carfilzomib is metabolized peripherally by plasma peptidases and only a proportion is metabolized in the liver through the CYP 3A4 pathway. Carfilzomib has minimal effect on CYP 3A4 activity and does not appear to be susceptible to drug-drug interactions with agents that inhibit or induce hepatic CYP 3A4 activity.

### Outcome and Management

Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to dose reduction or temporary cessation. Clinically apparent liver injury should prompt immediate interruption of carfilzomib therapy. There is little information on cross reactivity in risk for hepatic injury between carfilzomib and other cancer chemotherapeutic agents, including the tyrosine kinase inhibitors and other proteasome inhibitors such as bortezomib.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Carfilzomib – Kyprolis®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Carfilzomib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Carfilzomib | 868540-17-4 | C40-H57-N5-O7 | Carfilzomib chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 17 January 2017

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of proteasome inhibitors such as bortezomib or carfilzomib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents; bortezomib is listed as causing hepatocellular injury, but carfilzomib is not discussed).
Chabner BA, Barnes J, Neal J, Olson E, Mujagic H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-54. (Textbook of pharmacology and therapeutics).
Carfilzomib (Kryprolis) for multiple myeloma. Med Lett Drugs Ther 2012; 54 (1406): 103-4. Review. (Concise review of mechanism of action, efficacy and safety of carfilzomib as therapy for multiple myeloma shortly after its approval in the US; mentions hepatic failure as a serious adverse reaction). 23282792
Jagannath S, Vij R, Stewart AK, Trudel S, Jakubowiak AJ, Reiman T, Somlo G, Bahlis N, et al. An open-label single-arm pilot phase II study (PX-171-003-A0) of low-dose, single-agent carfilzomib in patients with relapsed and refractory multiple myeloma. Clin Lymphoma Myeloma Leuk 2012; 12: 310-8. (Among 46 patients with refractory multiple myeloma treated with carfilzomib, 7 were partial responders; side effects included anemia [74%], fatigue [70%] and thrombocytopenia [50%]; no mention of ALT elevations or hepatotoxicity and no deaths were considered secondary to therapy). 23040437
Siegel DS, Martin T, Wang M, Vij R, Jakubowiak AJ, Lonial S, Trudel S, et al. A phase 2 study of single-agent carfilzomib (PX-171-003-A1) in patients with relapsed and refractory multiple myeloma. Blood 2012; 120: 2817-25. (Among 266 patients with refractory multiple myeloma treated with carfilzomib, the overall response rate was 24% and side effects included fatigue, anemia, nausea, thrombocytopenia, and peripheral neuropathy; among 12 deaths were 2 from hepatic failure, one of which was considered possibly or probably related to carfilzomib therapy). 22833546
Jakubowiak AJ, Dytfeld D, Griffith KA, Lebovic D, Vesole DH, Jagannath S, Al-Zoubi A, et al. A phase 1/2 study of carfilzomib in combination with lenalidomide and low-dose dexamethasone as a frontline treatment for multiple myeloma. Blood 2012; 120: 1801-9. (Among 53 patients with multiple myeloma treated with carfilzomib, lenalidomide and dexamethasone in 28 day cycles, elevated liver tests occurred in 8% of patients). 22665938
Kortuem KM, Stewart AK. Carfilzomib. Blood 2013; 121: 893-7. (Overview of the second generation proteasome inhibitor carfilzomib which, unlike bortezomib, is an irreversible inhibitor and is not metabolized by the CYP 3A4 system to a major extent). 23393020
Siegel D, Martin T, Nooka A, Harvey RD, Vij R, Niesvizky R, Badros AZ, et al. Integrated safety profile of single-agent carfilzomib: experience from 526 patients enrolled in 4 phase II clinical studies. Haematologica 2013; 98: 1753-61. (Summary of safety assessment in 526 patients with advanced multiple myeloma treated with carfilzomib; any hepatic event occurred in 99 [19%] of patients, increased AST in 66 [12%] and ALT in 43 [8%] and hepatic failure in 2, but no patient had concurrent ALT and bilirubin elevation attributable to carfilzomib). 23935022
Herndon TM, Deisseroth A, Kaminskas E, Kane RC, Koti KM, Rothmann MD, Habtemariam B, et al. U.S. Food and Drug Administration approval: carfilzomib for the treatment of multiple myeloma. Clin Cancer Res 2013; 19: 4559-63. (Description of the accelerated approval of carfilzomib as therapy for multiple myeloma from the FDA; review of adverse reactions among 526 treated patients mentions AST elevations occurring in 66 [13%], with 6 [~1%] above 5 times ULN, and that 2 patients died of hepatic failure having entered the study with normal liver tests). 23775332
Bringhen S, Petrucci MT, Larocca A, Conticello C, Rossi D, Magarotto V, Musto P, et al. Carfilzomib, cyclophosphamide, and dexamethasone in patients with newly diagnosed multiple myeloma: a multicenter, phase 2 study. Blood 2014; 124: 63-9. (Among 58 patients with multiple myeloma treated with carfilzomib combined with cyclophosphamide and dexamethasone, 95% had at least a partial response; ALT or AST elevations occurred in 4 patients [7%], but all were less than 5 times ULN). 24855212
Harvey RD. Incidence and management of adverse events in patients with relapsed and/or refractory multiple myeloma receiving single-agent carfilzomib. Clin Pharmacol 2014; 6: 87-96. (Review of the published adverse reactions of carfilzomib therapy and recommendations for their management; among 37 deaths occurring during or shortly after therapy, seven were considered at least possibly related to carfilzomib, including one due to hepatic failure). 24855395
Shely RN, Ratliff PD. Carfilzomib-associated tumor lysis syndrome. Pharmacotherapy 2014; 34: e34-7. (55 year old man with multiple myeloma developed tumor lysis syndrome after first two infusions of carfilzomib, with marked rises in uric acid [15.9 mg/dL] and phosphorus [10.4 mg/dL] and death on day 8; no mention of liver tests). 24390940
Wang H, Guan F, Chen D, Dou QP, Yang H. An analysis of the safety profile of proteasome inhibitors for treating various cancers. Expert Opin Drug Saf 2014: 13: 1043-54. (Review of efficacy and safety of bortezomib and second generation proteasome inhibitors including carfilzomib, marizomib, ixazomib and oprozomib, states that "Carfilzomib has a favorable and tolerable safety profile"; no discussion of hepatotoxicity or serum enzyme elevations). 25005844
Lendvai N, Hilden P, Devlin S, Landau H, Hassoun H, Lesokhin AM, Tsakos I, et al. A phase 2 single-center study of carfilzomib 56 mg/m2 with or without low-dose dexamethasone in relapsed or refractory multiple myeloma. Blood 2014 Jun 24. [Epub ahead of print] (Among 44 patient with refractory multiple myeloma previously treated with bortezomib given carfilzomib, 55% had at least a partial response and side effects included lymphopenia [55%], thrombocytopenia [32%], hypertension [25%], pneumonia [18%] and heart failure [11%]; no mention of ALT elevations or hepatotoxicity). 24963043
Schlafer D, Shah KS, Panjic EH, Lonial S. Safety of proteasome inhibitors for treatment of multiple myeloma. Expert Opin Drug Saf 2016: 1-17. [Epub ahead of print] (Review of the toxicities of the proteasome inhibitors; does not mention hepatotoxicity or ALT elevations). 27841029
Muchtar E, Gatt ME, Rouvio O, Ganzel C, Chubar E, Suriu C, Tadmor T, et al. Efficacy and safety of salvage therapy using carfilzomib for relapsed or refractory multiple myeloma patients: a multicentre retrospective observational study. Br J Haematol 2016; 172: 89-96. (Among 135 patients with relapsed or refractory multiple myeloma treated with carfilzomib usually in combination with dexamethasone and often with lenilidamide, the overall response rate was 47% and adverse events included liver enzyme elevations in 19% which were above 5 times ULN in 4% and 1 of 7 deaths was attributed to acute hepatic failure death considered related to therapy). 26567759
Dimopoulos MA, Moreau P, Palumbo A, Joshua D, Pour L, Hájek R, Facon T, et al; ENDEAVOR Investigators.. Carfilzomib and dexamethasone versus bortezomib and dexamethasone for patients with relapsed or refractory multiple myeloma (ENDEAVOR): a randomised, phase 3, open-label, multicentre study. Lancet Oncol 2016; 17: 27-38. (Among 929 patients with refractory multiple myeloma treated with dexamethasone and carfilzomib or bortezomib, progression-free but not overall survival was longer with carfilzomib than bortezomib, while adverse event rates were similar, ALT elevations occurring in 4.5% vs 3.9% and rising above 5 times ULN in 1.1% vs 0.4%). 26671818

## OTHER REFERENCE LINKS

1. Recent References on Carfilzomib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Carfilzomib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Carfilzomib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Carfilzomib)